# Nicardipine

## OVERVIEW

### Introduction

Nicardipine is a second generation calcium channel blocker used in the treatment of hypertension and stable angina pectoris. Nicardipene therapy has been associated with a low rate of transient serum enzyme elevations, but has not been linked convincingly to instances of clinically apparent liver injury with jaundice.

### Background

Nicardipine (nye kar' di peen) belongs to the dihydropyridine class of calcium channel blockers and is used in the treatment of both angina pectoris and hypertension. Like other calcium channel blockers, nicardipine acts by blocking the influx of calcium ions into vascular smooth muscle and cardiac cells during depolarization. This inhibition of calcium flux results in a vasodilation and decrease in cardiac work and oxygen consumption. Nicardipine was approved in the United States in 1988 and in remains in wide use. Nicardipine is available in multiple generic forms and under the commercial name Cardene in regular and as extended- or sustained-release capsules in 20, 30, 45 and 60 mg amounts. The current indications vary by formulation, but include both hypertension and angina pectoris. The usual adult dose is 60 to 120 mg daily in 2 or 3 divided doses. Intravenous formulations are available for management of hypertensive emergencies. As with other calcium channel blockers, nicardipine is generally well tolerated and side effects are largely due to its vasodilating activities and can include headache, flushing, dizziness, fatigue, nausea, diarrhea, peripheral edema and skin rash.

### Hepatotoxicity

Nicardipine has not been associated with significant increases in rates of elevations in serum aminotransferase or alkaline phosphatase levels, even with chronic long term therapy. Cases of idiosyncratic liver injury have not been published, although a single instance of marked serum enzyme elevations without jaundice has been reported with the use of intravenous nicardipine. Large trials of nicardipine have not mentioned liver injury, serum aminotransferase elevations or discontinuation of drug because of hepatic adverse events. Thus, clinically apparent liver injury with jaundice due to nicardipine must be rare, if it occurs at all.

Likelihood Score: E (unlikely cause of clinically apparent liver injury).

The reason why some calcium channel blockers are known to cause idiosyncratic liver injury while others such as nicardipine do not, is unknown.

Drug Class: Cardiovascular Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Amlodipine, Diltiazem, Felodipine, Isradipine, Nifedipine, Nimodipine, Nisoldipine, Verapamil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nicardipine – Generic, Cardene®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nicardipine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Nicardipine | 55985-32-5 | C26-H29-N3-O6 | Nicardipine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 January 2017

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999; among calcium channel blockers, diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury; nicardipine is not discussed, but is listed as potentially causing hepatocellular injury ).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of calcium channel blockers mentions that diliazem, nifedipine and verapamil have been implicated in causing cholestatic liver injury in a small number of patients; nicardipine is not discussed).
Michel T, Hoffman BB. Calcium channel antagonists. Treatment of myocardial ischemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 755-60. (Textbook of pharmacology and therapeutics).
Agre K. An overview of the safety and efficacy of nicardipine in clinical trials. Am J Cardiol 1987; 59: 31J-35J. (In studies of over 2000 patients treated with nicardipine, no serious liver related adverse events were reported: "A number of abnormalities were detected, but they were sporadic and inconsistent"). 3300239
Kuwajima I, Kuramoto K, Ogihara T, et al. Tolerability and safety of a calcium channel blocker in comparison with a diuretic in the treatment of elderly patients with hypertension: secondary analysis of the NICS-EH. Hypertens Res 2001; 24: 475-80. (In studies on 429 elderly subjects, there were fewer side effects from nicardipine than with diuretics and no reports of liver related adverse events). 11675939
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a calcium channel blocker). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16165719) (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; only one case was possibly linked to a calcium channel blocker: felodipine).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18955056) (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil] and as one of several agents in 2 cases [both amlodipine]).
Chaudhry M, Maqsood A, Diab-Agha S, Rosenberg J. Nicardipine-induced acute hepatitis in an intensive care unit patient. Am J Ther 2009 16: 71-3. (62 year old man with acute myocardial infarction was given nicardipine intravenously and developed fever and serum enzyme elevations 4 days later [bilirubin normal, ALT 356 U/L, Alk P 299 U/L], resolving within days of stopping). 19092642
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to calcium channel blockers). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23419359) (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but no cases were attributed to calcium channel blockers).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to isradipine or other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents including 4 due to calcium channel blockers [amlodipine in 1 and verapamil in 3 instances], but none to isradipine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Nicardipine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=nicardipine/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Nicardipine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nicardipine)